# Metoprolol

## OVERVIEW

### Introduction

Metoprolol is a cardioselective beta-blocker that is widely used in the treatment of hypertension and angina pectoris. Metoprolol has been linked to rare cases of drug induced liver injury.

### Background

Metoprolol (met" oh proe' lol) is considered a “selective” beta-adrenergic receptor blocker in that it has potent activity against beta-1 adrenergic receptors which are found in cardiac muscle, but has little or no activity against beta-2 adrenergic receptors found on bronchial and vascular smooth muscle. Metoprolol was approved for use in the United States in 1978 and is still widely used in the therapy of hypertension and angina pectoris, with more than 27 million prescriptions filled yearly. Metoprolol is also used to reduce the risk of cardiovascular mortality after acute myocardial infarction. Metoprolol is available in standard 50 and 100 mg tablets as well as 25, 50, 100 and 200 mg extended release tablets in generic forms as well as under the trade name of Lopressor and Toprol XL, and as a fixed combination with a hydrochlorothiazide as Lopressor HCT and Dutoprolol. Parenteral formulations for intravenous use are also available. The usual initial oral dose of metoprolol in adults is 100 mg daily in one or two divided doses daily, with subsequent adjustment based upon clinical response and tolerance, the usual maintenance dosage being 100 to 400 mg daily. The entended release forms are given in doses of 25 to 100 mg once daily. Common side effects include bradycardia, hypotension, fatigue, dizziness, depression, insomnia, memory loss and impotence. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes. As with all beta-blockers, sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Metoprolol therapy has been associated with a low rate of mild-to-moderate elevations of serum aminotransferase levels which are usually asymptomatic and transient and resolve even with continuation of therapy. A few instances of clinically apparent, acute liver injury attributable to metoprolol have been reported. In view of its wide scale use, metoprolol induced liver injury is exceedingly rare. The typical liver injury associated with beta-blockers has a latency to onset of 2 to 12 weeks and a hepatocellular pattern of liver enzyme. Symptoms of hypersensitivity (rash, fever, eosinophilia) and autoantibody formation have not been reported. Reported cases due to metoprolol have included cases of acute liver failure, but ultimately all were self-limiting and resolved fairly rapidly once once drug was stopped.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of drug induced liver injury from metoprolol is not known. The agent is metabolized in the liver via the cytochrome P450 (largely CYP 2D6). The rare instances of liver injury due to beta-blockers are likely to be idiosyncratic.

### Outcome and Management

The severity of liver injury due to metoprolol ranges from mild serum aminotransferase elevations to mild acute hepatitis with jaundice. In large case series of acute liver failure due to medications, metoprolol has not been listed as a cause. Rechallenge has been reported to result in recurrence of injury and should be avoided. There is little information about cross reactivity among the beta-blockers to hepatic injury. Switching to another beta-blocker after metoprolol related acute liver injury should be done with caution and prospective monitoring.

References to the safety and potential hepatotoxicity of metoprolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## CASE REPORT

### Case 1. Metoprolol induced acute liver injury.

[Modified from: Larrey D, Henrion J, Heller F, Babany G, Degott C, Pessayre D, Benhamou JP. Metoprolol-induced hepatitis: rechallenge and drug oxidation phenotyping. Ann Intern Med 1988; 108:67-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3337519)]

A 56 year old woman developed fatigue and abdominal pains 2 weeks after starting metoprolol (50 mg daily) for migraine headaches. She had no previous history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. She had been treated with doxycycline, aspirin and a cough suppressant two weeks earlier for an acute bronchitis. She had no jaundice, fever or rash. Laboratory testing showed marked elevations in serum aminotransferase with minimal increase in alkaline phosphatase levels and normal serum bilirubin (Table). All liver tests had been normal in the past. Tests for hepatitis A and B and for autoantibodies were negative. An abdominal ultrasound was normal. A liver biopsy showed moderate steatosis and occasional ballooned hepatocyte without inflammation or fibrosis. Metoprolol was discontinued and she rapidly improved symptomatically. Within 3 weeks, liver tests were normal. Rechallenge led to a recurrence of liver injury.

#### Key Points

Medication: | Metoprolol (200 mg daily)
Pattern: | Hepatocellular (R=19)
Severity: | 1+ (enzyme elevations and symptoms without jaundice)
Latency: | 3 weeks
Recovery: | 3 weeks
Other medications: | Doxycycline, aspirin and cough suppressant 3 weeks previously

#### Laboratory Values

Time After Starting | Weeks After Stopping | ALT* (U/L) | Alk P* (U/L) | GGT* (mg/dL) | Other
Pre | | 26 | 72 | 20
Metoprolol (50 mg daily) given for 3 weeks
3 weeks | 0 | 1140 | 168 | 244 | Bilirubin 0.7 mg/dL
| 2 days | 409 | 132 | 154
4 weeks | 5 days | 171 | 108 | 110
6 weeks | 3 weeks | 34 | 84 | 34
Metoprolol (50 mg daily) restarted for 5 days
5 days | 0 | 66 | 144 | Not done
7 weeks | 6 weeks | 24 | 126 | 26
Normal Values | | <40 | <110 | <50

* Converted from μKat/L.

#### Comment

This patient developed an anicteric acute hepatitis-like clinical picture three weeks after starting metoprolol. A history of exposure to doxycycline raised the issue of whether the acute injury was due to metoprolol or to a delayed reaction to doxycycline, and a rechallenge was performed a few weeks after recovery. Within a week, serum ALT and alkaline phosphatase levels had increased and metoprolol was stopped. The short latency period, mild acute hepatocellular injury and rapid recovery are typical of the liver injury reported with beta-blockers.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metoprolol – Generic, Lopressor®, Toprol®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=metoprolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Metoprolol | 51384-51-1 | C15-H25-N-O3 | Metoprolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Metoprolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Metoprolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Metoprolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Metoprolol)